# Ustekinumab

## OVERVIEW

### Introduction

Ustekinumab is a human monoclonal antibody to a polypeptide found on interleukin-12 and -23 that is used to treat autoimmune conditions and is approved for use in severe psoriasis. Ustekinumab is associated with a low rate of serum enzyme elevations during therapy, but has not been linked to cases of idiosyncratic, clinically apparent liver injury. Ustekinumab has immunomodulatory activity and may cause reactivation of hepatitis B in susceptible patients.

### Background

Ustekinumab (us” te kin’ ue mab) is a human monoclonal immunoglobulin G1 antibody to the p40 subunit polypeptide of both interleukin (IL)-12 and -23, cytokines that are important mediators of autoimmune reactions. IL-12 and IL-23 are found in the skin lesions of psoriasis and in the affected gastrointestinal mucosa of patients with inflammatory bowel disease. Ustekinumab was approved for use in psoriasis United States in 2010, and indications were subsequently expanded to include inflammatory bowel disease. Current indications include moderate-to-severe plaque psoriasis and active psoriatic arthritis, Crohn disease and ulcerative colitis. Ustekinumab has been evaluated in other autoimmune diseases including Crohn disease, but does not have official approval for use in other conditions. Ustekinumab is available in liquid solution in single use vials and prefilled syringes of 45 and 90 mg (90 mg/mL) under the brand name Stelara. The initial and maintenance dose and dose regimen varies by indication and body weight. After an initial loading doses, ustekinumab is typically given subcutaneously every 8 to 12 weeks. Side effects are usually mild, and may include infusion reactions, chills, fever, skin rash, fatigue, leukopenia and infections. Less common, but potentially severe side effects include serious infections, reactivation of tuberculosis, increased risk of malignancies and reversible posterior leukoencephalopathy syndrome (RPLS).

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations were reported to occur in 0.5% to 1.4% of patients during ustekinumab therapy. The elevations, however, were self-limited and resolved even with continuing cyclic therapy and were no more frequent than occurred with placebo. Neither during premarketing evaluation nor subsequently have there been case reports of clinically apparent, acute liver injury with symptoms or jaundice linked to ustekinumab therapy, but experience with its use has been limited.

Ustekinumab has immunosuppressive activity and it has been linked to rare instances of reactivation of hepatitis B. HBV reactivation typically occurs in patients with preexisting HBsAg and relatively inactive disease. Reactivation causes acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. Cases of reactivation attributed to ustekinumab, however, have generally been mild, self-limited and not associated with symptoms or even ALT elevations. Screening for hepatitis B before starting ustekinumab is not recommended in the product label, but screening has been considered to be “advisable” by academic societies in published guidelines on psoriasis therapy. Ustekinumab has not been linked convincingly to worsening of chronic hepatitis C in patients with psoriasis or to hepatic decompensation in patients with pre-existing cirrhosis. For these reasons, chronic liver disease and concurrent HCV infection are not considered contraindications to therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury, possibly reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to newly expressed viral antigens. Injury generally arises between courses of immunosuppressive therapy, which for ustekinumab is given every 8 or 12 weeks after induction (at 0 and 4 weeks).

### Outcome and Management

Ustekinumab is a rare cause of liver injury, but has been linked to occasional cases of reactivation of hepatitis B. The product label for ustekinumab does not recommend routine screening for hepatitis B before initiation of therapy. However, guidelines for management of patients who are to receive ustekinumab prepared by some academic societies have recommended routine screening before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for persons who have HBsAg in serum. An alternative approach, which is perhaps more appropriate for ustekinumab and particularly for patients with anti-HBc without HBsAg in serum, is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise.

Drug Class: Dermatological Agents, Psoriasis Agents; Antirheumatic Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ustekinumab – Stelara®

DRUG CLASS

Dermatological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=c77a9664-e3bb-4023-b400-127aa53bca2b)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ustekinumab | 815610-63-0 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2020

Abbreviations: TNF, tumor necrosis factor; HER-2, human epidermal growth factor receptor 2; IL-17, interleukin 17.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; does not mention ustekinumab specifically, but discusses the problems of reactivation of hepatitis B and states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the tumor necrosis factor [TNF] alpha antagonists").
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Leonardi CL, Kimball AB, Papp KA, Yeilding N, Guzzo C, Wang Y, Li S, et al. (2008). PHOENIX 1 study investigators. Efficacy and safety of ustekinumab, a human interleukin-12/23 monoclonal antibody, in patients with psoriasis: 76-week results from a randomised, double-blind, placebo-controlled trial (PHOENIX 1). Lancet. (Among 766 patients with psoriasis treated with 1 of 2 doses of ustekinumab or placebo for 12 weeks, response rates were 67% and 66% with ustekinumab vs 3% with placebo, and side effects were similar and "results of laboratory results were much the same" in the 3 groups).
Papp KA, Langley RG, Lebwohl M, Krueger GG, Szapary P, Yeilding N, Guzzo C, et al. (2008). PHOENIX 2 study investigators. Efficacy and safety of ustekinumab, a human interleukin-12/23 monoclonal antibody, in patients with psoriasis: 52-week results from a randomised, double-blind, placebo-controlled trial (PHOENIX 2). Lancet. (Among 1230 patients with psoriasis treated for 12 weeks with 1 of 2 doses of ustekinumab or placebo, clinical response rates were 67% and 76% with ustekinumab vs 4% with placebo, and "rates of laboratory abnormalities were similar between groups, and no differences were noted in liver aminotransferase concentrations").
Gottlieb A, Menter A, Mendelsohn A, Shen YK, Li S, Guzzo C, et al. (2009). Ustekinumab, a human interleukin 12/23 monoclonal antibody, for psoriatic arthritis: randomised, double-blind, placebo-controlled, crossover trial. Lancet. (Among 146 patients with psoriatic arthritis treated with either ustekinumab or placebo, responses at week 12 were more frequent with ustekinumab [42% vs 10%] and, while overall rates of adverse events were similar [61% vs 63%], ALT elevations occurred in 4% of ustekinumab vs 1% of placebo recipients).
Griffiths CE, Strober BE, van de Kerkhof P, Ho V, Fidelus-Gort R, Yeilding N, Guzzo C, et al., ACCEPT Study Group. (2010). Comparison of ustekinumab and etanercept for moderate-to-severe psoriasis. N Engl J Med. (Among 903 patients with psoriasis treated with 1 of 2 doses of ustekinumab vs etanercept for 12 weeks, clinical response rates were higher with ustekinumab [68-74% vs 57%], while rates of ALT elevations were similar [0.5-0.9% vs 1.2%]).
(2010). Ustekinumab (Stelara) for psoriasis. Med Lett Drugs Ther. (Concise summary of mechanism of action, efficacy, safety and costs of ustekinumab in patients with psoriasis, mentions possibility of reactivation of tuberculosis, but not reactivation of hepatitis B, ALT elevations or hepatotoxicity).
Tsai TF, Ho JC, Song M, Szapary P, Guzzo C, Shen YK, Li S, et al. (2011). PEARL Investigators. Efficacy and safety of ustekinumab for the treatment of moderate-to-severe psoriasis: a phase III, randomized, placebo-controlled trial in Taiwanese and Korean patients (PEARL). J Dermatol Sci. (Among 121 patients with psoriasis treated with ustekinumab or placebo for 12 weeks, response rates with greater with ustekinumab [67% vs 5%], while "abnormal hepatic function" was less [0% vs 3.3%], although with long term ustekinumab therapy enzyme elevations were more common [7.3-8.5%], most abnormalities however being attributed to concurrent isoniazid therapy).
Oketani M, Ido A, Tsubouchi H. (2011). Changing etiologies and outcomes of acute liver failure: A perspective from Japan. J Gastroenterol Hepatol. (Analysis of from multicenter study in Japan lists reactivation of HBV as an increasing cause of acute liver failure).
Mastroianni CM, Lichtner M, Citton R, Del Borgo C, Rago A, Martini H, Cimino G, et al. (2011). Current trends in management of hepatitis B virus reactivation in the biologic therapy era. World J Gastroenterol. (Review of the cause and risk factors for reactivation of HBV and the role of preventive strategies).
Opel D, Economidi A, Chan D, Wasfi Y, Mistry S, Vergou T, Antoniou C, Sofen H. (2012). Two cases of hepatitis B in patients with moderate to severe psoriasis with ustekinumab. J Drugs Dermatol. (Two men, 33 and 40 years old, with severe psoriasis developed acute hepatitis B during ustekinumab therapy and recovered with clearance of HBsAg).
Lebwohl M, Leonardi C, Griffiths CE, Prinz JC, Szapary PO, Yeilding N, Guzzo C, et al. (2012). Long-term safety experience of ustekinumab in patients with moderate-to-severe psoriasis (Part I of II): results from analyses of general safety parameters from pooled Phase 2 and 3 clinical trials. J Am Acad Dermatol. (Analysis of aggregate safety data from 3219 patients in 4 controlled trials of ustekinumab in psoriasis with variable extension periods reported "no notable differences in routine laboratory parameters were observed between patients treated with ustekinumab or placebo").
Gordon KB, Papp KA, Langley RG, Ho V, Kimball AB, Guzzo C, Yeilding N, et al. (2012). Long-term safety experience of ustekinumab in patients with moderate to severe psoriasis (Part II of II): results from analyses of infections and malignancy from pooled phase II and III clinical trials. J Am Acad Dermatol. (Analysis of aggregate safety data from 4 controlled trials of ustekinumab with extension for up to 3 years demonstrated no increase in rates of serious and opportunistic infections or malignancy; no analysis of ALT elevations or mention of hepatotoxicity).
Sandborn WJ, Gasink C, Gao LL, Blank MA, Johanns J, Guzzo C, Sands BE, et al., CERTIFI Study Group. (2012). Ustekinumab induction and maintenance therapy in refractory Crohn's disease. N Engl J Med. (Among 526 patients with Crohn disease treated with 1 of 3 doses of ustekinumab or placebo for 16 weeks, response rates were higher with ustekinumab [34-40% vs 24%] and rates of adverse events were similar; no mention of ALT elevations or hepatotoxicity).
Chiu HY, Chen CH, Wu MS, Cheng YP, Tsai TF. (2013). The safety profile of ustekinumab in the treatment of patients with psoriasis and concurrent hepatitis B or C. Br J Dermatol. (Among 18 patients with psoriasis and concurrent hepatitis B or C treated with ustekinumab, reactivation of HBV occurred in 2 of 11 with HBsAg, but with a rise in HBV DNA levels only, without symptoms or ALT elevations, while reactivation of HCV occurred in 1 of 4 patients marked by a rise in HCV RNA without change in ALT).
Abuchar A, Vitiello M, Kerdel FA. (2013). Psoriasis treated with ustekinumab in a patient with hepatitis C. Int J Dermatol. (62 year old man with psoriatic arthritis and chronic hepatitis C was treated with ustekinumab after intolerance or failure of other therapies and had no change in serum HCV RNA or ALT levels during the first few months of therapy).
McInnes IB, Kavanaugh A, Gottlieb AB, Puig L, Rahman P, Ritchlin C, Brodmerkel C, et al. (2013). PSUMMIT 1 Study Group. Efficacy and safety of ustekinumab in patients with active psoriatic arthritis: 1 year results of the phase 3, multicentre, double-blind, placebo-controlled PSUMMIT 1 trial. Lancet. (Among 615 patients with psoriatic arthritis treated with 1 of 2 doses of ustekinumab or placebo, response rates at 12 weeks were greater with ustekinumab [42-49% vs 23%], while rates of adverse events were similar).
Zhu X, Zheng M, Song M, Shen YK, Chan D, Szapary PO, Wang B. (2013). LOTUS Investigators. Efficacy and safety of ustekinumab in Chinese patients with moderate to severe plaque-type psoriasis: results from a phase 3 clinical trial (LOTUS). J Drugs Dermatol. (Among 322 Chinese patients with psoriasis treated with 2 injections of ustekinumab or placebo, responses at week 12 were 83% with ustekinumab vs 11% with placebo, while ALT elevations occurred in only 1 patient in each group (<1%) and resolved spontaneously).
Papp KA, Griffiths CE, Gordon K, Lebwohl M, Szapary PO, Wasfi Y, Chan D, et al. (2013). PHOENIX 1 Investigators; PHOENIX 2 Investigators; ACCEPT Investigators. Long-term safety of ustekinumab in patients with moderate-to-severe psoriasis: final results from 5 years of follow-up. Br J Dermatol. (Pooled analysis of 4 controlled trials of ustekinumab for psoriasis in 3117 patients found no excess in serious adverse events with long term ustekinumab therapy).
Navarro R, Vilarrasa E, Herranz P, Puig L, Bordas X, Carrascosa JM, Taberner R, et al. (2013). Safety and effectiveness of ustekinumab and antitumour necrosis factor therapy in patients with psoriasis and chronic viral hepatitis B or C: a retrospective, multicentre study in a clinical setting. Br J Dermatol. (A retrospective analysis identified 3 patients with psoriasis and chronic hepatitis C and 3 with chronic hepatitis B who were treated with ustekinumab, none of whom had a significant change in ALT or viral levels during treatment).
Meng Y, Dongmei L, Yanbin P, Jinju F, Meile T, Binzhu L, Xiao H, et al. (2014). Systematic review and meta-analysis of ustekinumab for moderate to severe psoriasis. Clin Exp Dermatol. (Systematic review of 9 controlled trials of ustekinumab which included 11,381 patients mentions that the rate of adverse events [including serious infections] with treatment was similar to that in placebo controls; no mention of ALT elevations, hepatotoxicity or reactivation of hepatitis B).
Tamori A, Hino M, Kawamura E, Fujii H, Uchida-Kobayashi S, Morikawa H, Nakamae H, et al. (2014). A prospective long-term study of hepatitis B virus reactivation in patients with hematologic malignancy. J Gastroenterol Hepatol. (Among patients with anti-HBc without HBsAg not receiving prophylaxis, reactivation of HBV occurred in 26% of 19 patients undergoing HCT [onset at 9-36 months] and 10% of 30 patients given rituximab based chemotherapy [onset after 2-10 months], all of whom had anti-HBs titers below 200 mIU/mL before therapy and all of whom were successfully treated with entecavir).
Ritchlin C, Rahman P, Kavanaugh A, McInnes IB, Puig L, Li S, Wang Y, et al. (2014). PSUMMIT 2 Study Group. Efficacy and safety of the anti-IL-12/23 p40 monoclonal antibody, ustekinumab, in patients with active psoriatic arthritis despite conventional non-biological and biological anti-tumour necrosis factor therapy: 6-month and 1-year results of the phase 3, multicentre, double-blind, placebo-controlled, randomised PSUMMIT 2 trial. Ann Rheum Dis. (Among 312 patients with psoriatic arthritis in a 24 week controlled trial, clinical responses occurred in 44% of ustekinumab vs 20% of placebo recipients, and rates of side effects were similar without ustekinumab related severe adverse events or tuberculosis; no mention of ALT elevations or hepatotoxicity).
(2014). Certolizumab pegol (Cimzia) and ustekinumab (Stelara) for psoriatic arthritis. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, safety and cost of ustekinumab and certolizumab shortly after their approval for use in psoriatic arthritis; no mention of hepatotoxicity or reactivation of hepatitis B).
Motaparthi K, Stanisic V, Van Voorhees AS, Lebwohl MG, Hsu S, Medical Board of the National Psoriasis Foundation. (2014). From the Medical Board of the National Psoriasis Foundation: Recommendations for screening for hepatitis B infection prior to initiating anti-tumor necrosis factor-alfa inhibitors or other immunosuppressive agents in patients with psoriasis. J Am Acad Dermatol. (Mentions that little is known about the effects of ustekinumab on HBV infection, but that screening for hepatitis B markers is "advisable" before its use).
Steglich RB, Meneghello LP, Carvalho AV, Cheinquer H, Muller FM, Reginatto FP. (2014). The use of ustekinumab in a patient with severe psoriasis and positive HBV serology. An Bras Dermatol. (53 year old man with psoriasis and anti-HBc without HBsAg in serum was given lamivudine prophylaxis and treated with ustekinumab for 3 years with an excellent response and no evidence of reactivation of hepatitis B).
Llamas-Velasco M, Concha-Garzón MJ, García-Diez A, Daudén E. (2015). Liver injury in psoriasis patients receiving ustekinumab: a retrospective study of 44 patients treated in the clinical practice setting. Actas Dermosifiliogr. (Among 44 patients with psoriasis treated with ustekinumab for 1 to 5 years, 6 developed minor ALT elevations on therapy [peak values 39 to 74 U/L], but all resolved without jaundice and without dose modifications).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, only four cases were attributed to a monoclonal antibody [3 to infliximab and 1 to adalimumab; no cases were attributed to ustekinumab).
Sanz-Bueno J, Vanaclocha F, García-Doval I, Torrado R, Carretero G, Daudén E, Patricia Ruiz-Genao D, et al. (2015). members of the BIOBADADERM group. Risk of reactivation of hepatitis B virus infection in psoriasis patients treated with biologics: a retrospective analysis of 20 cases from the BIOBADADERM database. Actas Dermosifiliogr. (Among 20 patients with psoriasis who had anti-HBc without HBsAg in serum and were treated with biologic agents, none developed evidence of reactivation of hepatitis B including 6 who received ustekinumab for an average of 18 months).
Hirschfield GM, Gershwin ME, Strauss R, Mayo MJ, Levy C, Zou B, Johanns J, et al., PURIFI Study Group. (2016). Ustekinumab for patients with primary biliary cholangitis who have an inadequate response to ursodeoxycholic acid: A proof-of-concept study. Hepatology. (Among 20 patients with primary biliary cirrhosis treated with ustekinumab for up to 28 weeks, drop outs were frequent and serum alkaline phosphatase, ALT and AST improved minimally [9%-11%], no patients achieving criteria for a response, but also no patients developing worsening of blood test results; one subject had a variceal hemorrhage).
Snast I, Atzmony L, Braun M, Hodak E, Pavlovsky L. (2017). Risk for hepatitis B and C virus reactivation in patients with psoriasis on biologic therapies: A retrospective cohort study and systematic review of the literature. J Am Acad Dermatol. (Among 25 patients with psoriasis and anti-HBc without HBsAg in serum who were treated with biologic agents, including 9 treated with ustekinumab, none developed serum ALT elevations or evidence of HBV reactivation).
Lovero R, Losurdo G, Mastromauro M, Castellaneta NM, Mongelli A, Gentile A, Di Leo A, et al. (2018). A case of severe transaminase elevation following a single ustekinumab dose with remission after drug withdrawal. Curr Drug Saf. (61 year old woman with psoriasis developed marked ALT elevations after a single, initial injection of ustekinumab [ALT 1212 U/L] and recovered but was not retreated).
Ting SW, Chen YC, Huang YH. (2018). Risk of hepatitis B reactivation in patients with psoriasis on ustekinumab. Clin Drug Investig. (Among 93 patients with psoriasis treated with ustekinumab, 10 with HBsAg [2 given prophylaxis], 24 with anti-HBc without HBsAg, and 59 with no HBV markers [n=59], 2 with HBsAg, 1 with anti-HBc and none without markers developed reactivation of HBV during therapy, but all cases were asymptomatic with only minor and transient elevations in HBV DNA).
Begon E, Beneton N, Poiraud C, Droitcourt C, Jacobzone C, Vermersch-Langlin A, Descamps V, et al. (2018). Groupe d'Etudes Multicentrique GEM RESOPSO. Safety and efficacy of biological therapies in patients with psoriasis with alcoholic cirrhosis: a French retrospective study of 23 cases. Br J Dermatol. (Among 23 patients with alcoholic cirrhosis and psoriasis who were treated with biologic agents [10 with ustekinumab], therapy was often effective and was well tolerated and although 5 developed infections, all were able to continue or resume therapy).
AlMutairi N, Abouzaid HA. (2018). Safety of biologic agents for psoriasis in patients with viral hepatitis. J Dermatolog Treat. (Among 39 patients with psoriasis and chronic viral hepatitis treated with biologic agents for at least 24 months, all were monitored but none developed clinical, biochemical or virologic evidence of reactivation [4 with HBsAg were given prophylaxis; 28 with anti-HBc without HBsAg and 7 with chronic hepatitis C]).
Piaserico S, Messina F, Russo FP. (2019). Managing psoriasis in patients with HBV or HCV infection: practical considerations. Am J Clin Dermatol. (Review of the risks of reactivation of hepatitis B from biologic agents used to treat psoriasis mentions that ustekinumab has a moderate risk and recommends monitoring of HBV DNA levels during therapy if prophylaxis with antiviral agents is not used).
(2019). Drugs for psoriatic arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for psoriatic arthritis mentions that common adverse events from secukinumab include injection site reactions, respiratory and candida infections, nausea and diarrhea ad uncommon but severe adverse events include tuberculosis, Crohn disease and hypersensitivity reactions).
(2019). Drugs for psoriasis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for psoriasis mentions three IL-17A antagonists – secukinumab, ixekizumab and brodalumab – all of which are highly effective and relatively well tolerated; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Ustekinumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ustekinumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ustekinumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ustekinumab)